# Nilutamide

## OVERVIEW

### Introduction

Nilutamide is a first generation, oral nonsteroidal antiandrogen similar in structure to flutamide that is used in the therapy of prostate cancer. Nilutamide is associated with a low rate of serum aminotransferase elevations during therapy and with rare instances of clinically apparent, acute liver injury.

### Background

Nilutamide (nye loo' ta mide) is an anilide nonsteroidal antiandrogen that blocks the binding of endogenous androgens to intracellular androgen receptors blocking their effects. Nilutamide has been shown to be effective in reducing pain and disease progression in metastatic prostate cancer when administered in conjunction with orchiectomy or other antiandrogen agents such as luteinizing hormone releasing hormone (LHRH) agonists. Nilutamide was approved for use in the United States in 1996. Current indications are limited to the therapy of metastatic prostate cancer in combination with orchiectomy. Nilutamide is available generically and under the trade name Nilandron in 150 mg tablets, and the typically recommended dose is 300 mg daily starting at the time of orchiectomy with reduction of the dose to 150 mg daily one month later. Nilutamide is not approved for nor recommended for use in hyperandrogenic states such as hirsutism or acne. Common side effects include dizziness, impaired vision, fatigue, nausea, anorexia and weight loss. An uncommon but potentially serious adverse event is interstitial pneumonitis that occurs in approximately 2% of treated patients and that can progress to respiratory failure and death.

### Hepatotoxicity

In large registration clinical trials, ALT elevations occurred in 8% (range 2% to 33%) of patients during nilutamide therapy. The elevations were usually mild, asymptomatic and transient, requiring drug discontinuation in only 1% of treated patients. In rare instances, clinically apparent acute liver injury has occurred during nilutamide therapy, but the number of published cases are few, and the agent appears to be less hepatotoxic than flutamide. Nevertheless, fatal cases have been reported (Case 1). In reported cases, the latency to onset averaged 2 to 4 months and the clinical pattern of enzyme elevations was typically hepatocellular, thus largely resembling flutamide induced liver injury. Signs of hypersensitivity and autoimmunity were not common.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of nilutamide hepatotoxicity is unknown, but toxic metabolites of the agent may induce oxidative stress or interfere with mitochondrial function.

### Outcome and Management

The mild ALT elevations during nilutamide therapy are usually self-limiting even with continuation of the medication. The rare instances of clinically apparent liver injury are usually self-limiting, but several fatal instances have been reported. Monitoring of liver tests is recommended before starting treatment and at regular intervals thereafter, particularly during the first 4 months of treatment and therapy stopped if symptoms, jaundice or marked serum aminotransferase elevations arise. Rechallenge should be avoided. Patients with nilutamide hepatotoxicity should probably not receive flutamide and be given bicalutamide with caution.

Drug Class: Antineoplastic Agents, Antiandrogens

## CASE REPORTS

### Case 1. Acute liver failure from nilutamide therapy.(1)

A 65 year old man with prostate cancer developed jaundice 8 weeks after starting nilutamide for prostate cancer. Nilutamide was stopped promptly, but he continued to worsen and developed mental confusion and was admitted to a hospital. On examination, he was markedly jaundiced and had stage 2 hepatic encephalopathy (asterixis and confusion). His past medical history was negative for liver disease and he had no risk factors for viral hepatitis and rarely drank alcohol. He had been diagnosed with prostate cancer and underwent orchiectomy 3 months previously and was treated postoperatively for 3 weeks with norfloxacin and prednisolone. Liver tests were reported to be normal before he was started on nilutamide (150 mg/day) and leuprolide (an LHRH analog: 3.75 mg intramuscularly each month). At the time that nilutamide was stopped 8 weeks later, serum bilirubin was 7.5 mg/dL, and it rose rapidly thereafter (Table). Tests for hepatitis A, B and C, EBV and CMV as well as for autoantibodies were negative. Abdominal ultrasound showed no evidence of biliary disease. He developed progressive mental obtundation, coagulopathy and, not being a candidate for emergency liver transplantation, died 16 days after onset of jaundice. Post mortem liver biopsy showed massive necrosis with minimal fibrosis.

#### Key Points

Medication: | Nilutamide, 150 mg daily for 8 weeks
Pattern: | Hepatocellular
Severity: | 5+ (acute liver failure and death)
Latency: | 8 weeks
Recovery: | None
Other medications: | Leuprolide. Prednisolone and norfloxacin 2 months previously

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | 0 | Normal | Normal | Normal
Nilutamide 150 mg daily after orchiectomy for prostate cancer
10 weeks | 0 | 2360 | 231 | 7.5
12 weeks | 2 weeks | 1510 | 290 | 42.5 | Admission. Protime <15%
13 weeks | 3 weeks | Death from hepatic failure
Normal Values | | <40 | <350 | <1.2

#### Comment

Despite stopping nilutamide when jaundice was first identified, this patient developed progressive hepatic failure and died within weeks of onset of liver injury. The latency (2 months), pattern of serum enzyme elevations (markedly hepatocellular), and lack of other obvious causes for liver injury (viral hepatitis, alcoholism, biliary disease, ischemia) points strongly to the role of nilutamide. The overall clinical characteristics of nilutamide hepatotoxicity resemble those of flutamide, but clinically apparent liver disease appears to be less common.

### Case 2. Interstitial pneumonitis and mild elevations in serum enzymes during nilutamide therapy.(2)

A 69 year old man with prostate cancer developed shortness of breath and liver enzyme abnormalities 2 months after starting the combination of nilutamide and an luteinizing hormone releasing hormone (LHRH) analog. He had noticed progressive shortness of breath over the previous 4 weeks and was found to have tachypnea and abnormal chest x-ray findings suggestive of interstitial pneumonitis. Nilutamide was stopped. At the same time, blood test results showed mild elevations in ALT and alkaline phosphatase in comparison to pretreatment values. However, serum bilirubin levels were normal (Table). There was no eosinophilia and no signs of chronic liver disease or hepatic decompensation. Tests for viral hepatitis and autoantibodies were negative. A lung biopsy showed interstitial pneumonitis. In follow up, serum enzyme levels fell to pretreatment levels. He recovered slowly from the pulmonary complication. Flutamide was started after all test results returned to normal and was continued with no apparent toxic effects.

#### Key Points

Medication: | Nilutamide, 100 mg twice daily
Pattern: | Hepatocellular
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 2 months
Recovery: | 75 days
Other medications: | LHRH agonist

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | 0 | 12 | 127 | 0.40
Nilutamide 100 mg every 12 hours and LHRH agonist started for prostate cancer
8 weeks | 0 | 96 | 150 | 0.50 | Interstitial pneumonitis
18 weeks | 10 weeks | 13 | 132 | 0.40
Normal Values | | <35 | <130 | <1.2

#### Comment

Interstitial pneumonitis is an uncommon but well established complication of nilutamide therapy. Symptoms and signs reverse slowly and only partially after therapy is stopped. This patient was also found to have minor ALT elevations but not clinically apparent liver disease during therapy. In most situations, such minor ALT elevations can be monitored without dose modification. The fact that this patient tolerated flutamide therapy without subsequent evidence of liver injury does not indicate that there is no cross reactivity in instances of clinically apparent hepatotoxicity between these two agents. Switching therapy to flutamide is not recommended for patients with clinically apparent liver injury from nilutamide.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nilutamide – Generic, Nilandron®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nilutamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Nilutamide | 63612-50-0 | C12-H10-F3-N3-O4

## CITED REFERENCES

1 Marty F, Godart D, Doermann F, Mérillon H. (1996). Gastroenterol Clin Biol.
2 Gomez JL, Dupont A, Cusan L, Tremblay M, Tremblay M, Labrie F. (1992). Simultaneous liver and lung toxicity related to the nonsteroidal antiandrogen nilutamide (Anandron): a case report. Am J Med.

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2023

Abbreviations: LHRH, luteinizing hormone releasing hormone; PSA, prostate-specific antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 699. (Expert review of hepatotoxicity published in 1999, mentions that flutamide has led to instances of severe hepatic necrosis and fulminant hepatic failure).
DeLeve LD. Antiandrogens. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 612-3. (Textbook on drug induced liver injury mentions that nilutamide has been implicated in causing at least four cases of acute hepatitis, two of which were fatal).
Moy B, Lee RJ, Smith M. Hormone therapy in prostate cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1763-9. (Textbook of pharmacology and therapeutics; discusses the role of androgen receptor blockers in prostate cancer including bicalutamide, flutamide and nilutamide).
Hammel P, Ducreux M, Bismuth E, et al. (1991). Gastroenterol Clin Biol. (68 year old man with prostate cancer developed itching and then jaundice 4 months after starting nilutamide [bilirubin 8.2 mg/dL, ALT 22 times and Alk P 2 times ULN, eosinophils 800/μL], biopsy showed submassive necrosis; rapid improvement upon stopping with ultimate full recovery).
Gomez JL, Dupont A, Cusan L, Tremblay M, Tremblay M, Labrie F. (1992). Simultaneous liver and lung toxicity related to the nonsteroidal antiandrogen nilutamide (Anandron): a case report. Am J Med. (69 year old man with prostate cancer developed pulmonary toxicity [interstitial pneumonitis] 2 months after starting nilutamide with concurrent minor enzyme abnormalities [bilirubin 0.50 mg/dL, ALT 96 U/L, Alk P 150 U/L], which resolved rapidly with stopping: Case 2).
Pescatore P, Hammel P, Durand F, et al. (1993). Gastroenterol Clin Biol. (69 year old man with prostate cancer underwent orchiectomy and developed jaundice 8 weeks after starting nilutamide [bilirubin 13.9 mg/dL, ALT 45 times ULN], with progressive liver failure and death within 2 weeks; autopsy showed massive necrosis).
Bertagna C, De Géry A, Hucher M, François JP, Zanirato J. (1994). Efficacy of the combination of nilutamide plus orchidectomy in patients with metastatic prostatic cancer. A meta-analysis of seven randomized double-blind trials (1056 patients). Br J Urol. (Review of 7 randomized clinical trials of nilutamide in 1191 patients with prostate cancer showed improved pain and objective evidence of disease but not survival compared to placebo; no mention of hepatotoxicity).
Marty F, Godart D, Doermann F, Mérillon H. (1996). Gastroenterol Clin Biol. (65 year old man with prostate cancer developed jaundice 8 weeks after starting nilutamide [bilirubin 9.3 mg/dL, ALT 2360 U/L, Alk P 231 U/L], with rapid progression to liver failure and death 3 weeks later: Case 1).
Dijkman GA, Janknegt RA, De Reijke TM, Debruyne FM. (1997). Long-term efficacy and safety of nilutamide plus castration in advanced prostate cancer, and the significance of early prostate specific antigen normalization. International Anandron Study Group. J Urol. (Long term follow up of randomized clinical trials of nilutamide vs placebo after orchiectomy in 457 patients with prostate cancer; overall survival improved by 7 months, no new long term drug specific serious adverse event, no mention of hepatotoxicity).
McLeod DG. (1997). Tolerability of nonsteroidal antiandrogens in the treatment of advanced prostate cancer. Oncologist. (Overview of the safety and side effects of the nonsteroidal antiandrogens; ALT elevations occur in 2-33% receiving nilutamide compared to 4-62% with flutamide; 5 cases of clinically apparent hepatitis have been reported due to nilutamide, compared to more than 50 with flutamide).
Edouard A, Robinel R, Rat C, Lombard F, Lorinet C, Escarmant P. (2003). Gastroenterol Clin Biol. (67 year old man with prostate cancer developed jaundice 3 months after starting nilutamide [bilirubin 14.2 mg/dL, ALT 35 times and Alk P 1.5 times ULN, protime 42%], with progressive hepatic failure and death 4 weeks later).
Thole Z, Manso G, Salgueiro E, Revuelta P, Hidalgo A. (2004). Hepatotoxicity induced by antiandrogens: a review of the literature. Urol Int. (Systematic review of the literature from the Spanish pharmacovigilance group; 21 reports on hepatotoxicity of cyproterone, 46 flutamide, 4 nilutamide and only 1 bicalutamide; 6 cases of hepatocellular carcinoma linked to cyproterone therapy).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to an antiandrogen, perhaps because patients with prostate cancer would not be eligible for liver transplantation).
Manso G, Thole Z, Salgueiro E, Revuelta P, Hidalgo A. (2006). Spontaneous reporting of hepatotoxicity associated with antiandrogens: data from the Spanish pharmacovigilance system. Pharmacoepidemiol Drug Saf. (Analysis of spontaneous reporting to Spanish pharmacovigilance system found 88 cases of flutamide, 11 bicalutamide and 15 cyproterone hepatotoxicity, latency 3-6 months; 2 fatalities, both from flutamide; nilutamide not used in Spain).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; flutamide ranked 11th with a total of 59 cases).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to an antiandrogen).
Merwat SN, Kabbani W, Adler DG. (2009). Fulminant hepatic failure due to nilutamide hepatotoxicity. Dig Dis Sci. (76 year old man with prostate cancer developed abdominal pain followed by jaundice 6 weeks after starting nilutamide [bilirubin 25.8 mg/dL, ALT 1793 U/L, Alk P 231 U/L, INR 1.7], followed by progressive hepatic and multiorgan failure and death).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to antiandrogen therapies).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to bicalutamide, but none to nilutamide or other antiandrogens).
Crawford ED, Schellhammer PF, McLeod DG, Moul JW, Higano CS, Shore N, Denis L, et al. (2018). Androgen receptor targeted treatments of prostate cancer: 35 years of progress with antiandrogens. J Urol. (Review of the development of antiandrogen therapies of prostate cancer starting with discovery of the androgen sensitive nature of prostate cancer, the effects of orchiectomy, followed by the development of androgen receptor antagonists, first generation agents flutamide and nilutamide, second generation agent bicalutamide and third generation agents enzalutamide, apalutamide and darolutamide that have more potent androgen receptor inhibition).
Rashid M, Shamshavali K, Chhabra M. (2019). Efficacy and safety of nilutamide in patients with metastatic prostate cancer who underwent orchiectomy: a systematic review and metaanalysis. Curr Clin Pharmacol. (Systematic review identified 5 controlled trials of nilutamide in 1637 patients with prostate cancer, that showed improvements in both overall and progression free survival with nilutamide compared to placebo and adverse events included delayed adaption to darkness, blurred vision, alcohol intolerance, hot flashes, nausea, respiratory disorders and serum enzyme elevations).

## OTHER REFERENCE LINKS

1 Recent References on Nilutamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=nilutamide+AND+imidazolidines/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222006/01/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nilutamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nilutamide)